# Brentuximab Vedotin

## OVERVIEW

### Introduction

Brentuximab vedotin is a chimeric mouse-human monoclonal antibody to CD30 conjugated to a microtubule inhibitor, which is used in the therapy of Hodgkin lymphoma and anaplastic large cell lymphoma. Brentuximab vedotin has been linked to mild and transient serum enzyme elevations during therapy, but has not been implicated in cases of clinically apparent acute liver injury.

### Background

Brentuximab (bren tux’ i mab) vedotin (ve doe’ tin) is a chimeric mouse-human monoclonal antibody conjugate used as therapy for adults with Hodgkin lymphoma and anaplastic large cell lymphoma. The monoclonal conjugate is an IgG1 antibody to the human CD30 cell surface marker (also known as tumor necrosis factor receptor superfamily, member 8) which is expressed on malignant cells, particularly in Hodgkin lymphoma. The monoclonal antibody is conjugated to a microtubule inhibitor, monomethyl auristatin E (MMAE, also known as vedotin). When brentuximab vedotin binds to CD30, it is internalized and the MMAE is released by the action of lysosomal enzymes on the linker molecule that joins brentuximab to vedotin. The released vedotin causes apoptotic cell death of the cancerous cell. Brentuximab vedotin has been shown to be effective in inducing remissions in refractory Hodgkin lymphoma and anaplastic large cell lymphoma, and was approved for these indications in the United States in 2011. Brentuximab is available as a 50 mg lyophilized powder in single dose vials for reconstitution under the brand name Adcetris. The recommended regimen is 1.8 mg/kg by intravenous infusion every three weeks until disease progression or unacceptable toxicity. Dose reduction to 1.2 mg/kg is recommended for patients with mild liver dysfunction and avoidance of its use entirely in patients with moderate or severe liver dysfunction. Despite this fact, brentuximab vedotin has been used successfully in patients with Hodgkin disease and vanishing bile duct syndrome with serum bilirubin higher than 20 mg/dL. Common side effects include infusion reactions, peripheral neuropathy, fatigue, nausea, diarrhea, headache, skin rash, chills, fever, leucopenia and thrombocytopenia. Less common, but serious side effects include infections, severe cutaneous reactions including Stevens Johnson syndrome, tumor lysis syndrome, peripheral neuropathy, pulmonary toxicity and progressive multifocal leukoencephalopathy. Brentuximab should be prescribed and administered only by health care workers with expertise and experience in cancer chemotherapy and management of its adverse events.

### Hepatotoxicity

In publications on the large scale trials of brentuximab vedotin, rates of ALT elevations and clinically apparent liver injury were usually not mentioned. In a study of squamous cell carcinoma of the head and neck described in the product label, ALT elevations occurred in 45% of persons receiving brentuximab vedotin and radiation therapy versus 22% of those receiving radiation alone, but elevations above 5 times the ULN were rare (2% vs 1%). Isolated instances of transient serum aminotransferase elevations have been described with brentuximab vedotin therapy in the literature, usually arising during the initial course of treatment. The initial product label for brentuximab vedotin mentioned serious hepatotoxicity occurring in approximately 1% of patients including fatalities and recommended monitoring of liver enzyme and bilirubin levels during therapy. Subsequently, there has been at least one clinical description of severe acute liver injury with jaundice attributed to brentuximab vedotin, reports of 5 possible such cases from the sponsor, and 37 cases reported to the FDA’s Adverse Event Reporting System (FAERS).

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum enzyme elevations during brentuximab vedotin therapy is not known. However, the antibody conjugate or its break down products may be taken up and metabolized in liver cells to a small extent and cause direct hepatotoxicity. The cases of clinically apparent liver injury attributed to brentuximab vedotin have not resembled sinusoidal obstruction syndrome.

### Outcome and Management

The serum aminotransferase elevations that occur on brentuximab vedotin therapy are generally transient, mild and asymptomatic, and do not require dose modification or delay in therapy. Elevations above 5 times the upper limit of normal should lead to more careful monitoring and discontinuation or delay in therapy until levels return to normal or near normal levels. Serum ALT elevations above 20 times the ULN or with symptoms or jaundice should prompt permanent discontinuation. There is no information on cross reactivity of liver injury among the different monoclonal antibody conjugates.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

Other Monoclonal Antibody Conjugates: Benlantamab Mafodotin, Enfortumab Vedotin, Gemtuzumab Ozogamicin, Inotuzumab Ozogamicin, Polatuzumab Vedotin, Sacituzumab Govitecan, Tisotumab Vedotin, Trastuzumab Deruxtecan, Trastuzumab Emtansine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Brentuximab vedotin – Adcetris®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Brentuximab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Brentuximab Vedotin | 914088-09-8 (https://pubchem.ncbi.nlm.nih.gov/substance/135300399) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 10 January 2024

Abbreviations used: ABVD: Adriamycin, bleomycin, vincristine, and dacarbazine; HCT, hematopoietic cell transplantation; TNF, tumor necrosis factor.

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Bradley AM, Devine M, DeRemer D. Brentuximab vedotin: an anti-CD30 antibody-drug conjugate. Am J Health Syst Pharm 2013; 70: 589-97. (Review of the pharmacology, efficacy and safety of brentuximab vedotin; discussion of adverse events does not mention hepatotoxicity or ALT elevations). 23515511
Rothe A, Sasse S, Goergen H, Eichenauer DA, Lohri A, Jäger U, Bangard C, et al. Brentuximab vedotin for relapsed or refractory CD30+ hematologic malignancies: the German Hodgkin Study Group experience. Blood 2012; 120: 1470-2. (Among 45 patients with refractory Hodgkin lymphoma treated with 1-12 courses of brentuximab vedotin, side effects included peripheral neuropathy [31%], neutropenia [13%], thrombocytopenia [7%], fatigue and infections; no mention of ALT elevations or hepatotoxicity). 22786877
Pro B, Advani R, Brice P, Bartlett NL, Rosenblatt JD, Illidge T, Matous J, et al. Brentuximab vedotin (SGN-35) in patients with relapsed or refractory systemic anaplastic large-cell lymphoma: results of a phase II study. J Clin Oncol 2012; 30: 2190-6. (Among 58 patients with systemic anaplastic large cell lymphoma treated with 1 to 16 cycles of brentuximab vedotin, 85% had an objective response and side effects were common, but ALT elevations and hepatotoxicity were not mentioned). 22614995
Gopal AK, Ramchandren R, O'Connor OA, Berryman RB, Advani RH, Chen R, Smith SE, et al. Safety and efficacy of brentuximab vedotin for Hodgkin lymphoma recurring after allogeneic stem cell transplantation. Blood 2012; 120: 560-8. (Among 24 patients with recurrent Hodgkin lymphoma after HCT, 50% had an objective response to brentuximab vedotin and common side effects were cough, fatigue, fever, nausea, neuropathy and dyspnea, and common laboratory abnormalities were leucopenia, thrombocytopenia and decrease in phosphate; no mention of ALT elevations or hepatotoxicity). 22510871
Younes A, Gopal AK, Smith SE, Ansell SM, Rosenblatt JD, Savage KJ, Ramchandren R, et al. Results of a pivotal phase II study of brentuximab vedotin for patients with relapsed or refractory Hodgkin's lymphoma. J Clin Oncol 2012; 30: 2183-9. (Among 102 patients with recurrent Hodgkin lymphoma after HCT who were treated with brentuximab vedotin, peripheral neuropathy occurred in 42%; no mention of ALT elevations or hepatotoxicity). 22454421
Newland AM, Li JX, Wasco LE, Aziz MT, Lowe DK. Brentuximab vedotin: a CD30-directed antibody-cytotoxic drug conjugate. Pharmacotherapy 2013; 33: 93-104. (Review of mechanism of action, pharmacokinetics, efficacy and safety of brentuximab vedotin lists adverse effects of neutropenia [54-55%], peripheral neuropathy [52-53%], fatigue [41-49%], nausea [38-42%], diarrhea [29-36%], anemia [33-52%], fever [29-38%], rash [27-31%] and rare instances of anaphylaxis, tumor lysis syndrome, Stevens-Johnson syndrome, and progressive multifocal leukoencephalopathy [PMLE]; no mention of hepatotoxicity or ALT elevations). 23307550
Carson KR, Newsome SD, Kim EJ, Wagner-Johnston ND, von Geldern G, Moskowitz CH, Moskowitz AJ, et al. Progressive multifocal leukoencephalopathy associated with brentuximab vedotin therapy: A report of 5 cases from the Southern Network on Adverse Reactions (SONAR) project. Cancer 2014; 120 (16): 2464-71. (Clinical description of 5 cases of progressive multifocal leukoencephalopathy arising during brentuximab vedotin therapy; usually after 2-6 doses, 3-34 weeks after starting, presenting with aphasia, dysarthria, confusion, hemiparesis or gait disturbance; 4 of 5 patients died 6-16 weeks after onset). 24771533
Monjanel H, Deville L, Ram-Wolff C, Venon MD, Franchi P, Benet C, de Kerviler E, et al. Brentuximab vedotin in heavily treated Hodgkin and anaplastic large-cell lymphoma, a single centre study on 45 patients. Br J Haematol 2014; 166 (2): 306-8. (Among 45 patients with Hodgkin lymphoma or large cell lymphoma treated with brentuximab vedotin, 1 patient had "grade 3 hepatic cytolysis" that was rapidly reversible). 24673542
Urru SA, Mariotti E, Carta P, Massidda S, Marcias M, Murru R, Sanna P, Angelucci E. Acute pancreatitis following brentuximab vedotin therapy for refractory Hodgkin lymphoma: a case report. Drugs R D 2014; 14: 9-11. (65 year old man with refractory Hodgkin lymphoma developed elevated ALT levels after 1st infusion and nausea and epigastric pain shortly after 2nd leading to hospitalization [amylase 206 U/L, lipase 429 U/L, ALT and bilirubin 2-3 times ULN, neutropenia], but with rapid recovery and subsequent tolerance of further regimens). 24493291
Younes A. Brentuximab vedotin for the treatment of patients with Hodgkin lymphoma. Hematol Oncol Clin North Am 2014; 28: 27-32. (Short review of the efficacy of brentuximab vedotin in Hodgkin lymphoma; no mention of hepatotoxicity). 24287065
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5%] were attributed to antineoplastic agents and 5 [0.5%] to monoclonal antibodies [infliximab, adalimumab and ipilimumab], but none were linked specifically to brentuximab). 25754159
Chen R, Palmer JM, Martin P, Tsai N, Kim Y, Chen BT, Popplewell L, et al. Results of a multicenter phase II trial of brentuximab vedotin as second-line therapy before autologous transplantation in relapsed/refractory Hodgkin lymphoma. Biol Blood Marrow Transplant 2015; 21: 2136-40. (Among 37 patients with refractory Hodgkin lymphoma treated with brentuximab vedotin for a total of 4 cycles, overall response rate was 68%, the "toxicity profile was mild" and ALT elevations occurred in 38%, although none were above 5 times ULN or associated with jaundice). 26211987
Kim YH, Tavallaee M, Sundram U, Salva KA, Wood GS, Li S, Rozati S, et al. Phase II investigator-initiated study of brentuximab vedotin in mycosis fungoides and Sézary syndrome with variable CD30 expression level: a multi-institution collaborative project. J Clin Oncol 2015; 33: 3750-8. (Among 32 patients with mycosis fungoides or Sézary syndrome treated with brentuximab vedotin every 3 weeks for up to 16 courses, 21 [64%] had a clinical response and common adverse events included peripheral neuropathy [66%], fatigue [47%], nausea [28%] and neutropenia [19%], but there was no mention of ALT elevations or hepatotoxicity). 26195720
Gupta A, Petrasek J, Sen S, Gopal P, Naina HV. Single-agent brentuximab as bridging therapy for Hodgkin lymphoma patients with hepatic impairment. Clin Lymphoma Myeloma Leuk. 2016;16:e11-4. (Among 5 patients presenting with Hodgkin disease and unexplained liver abnormalities with jaundice [bilirubin 7-21 mg/dL, ALT 67-1187 U/L, Alk P 254-1223 U/L] thought to be due to hepatic lymphoma in 2, vanishing bile duct syndrome in 2, and drug induced liver injury 1, who were treated with brentuximab vedotin as first line therapy, all had at least a partial response and improvement in the liver abnormalities that then allowed standard first line therapy with doxorubicin, bleomycin, vincristine and dacarbazine [ABVD]). 26775723
Prince HM, Kim YH, Horwitz SM, Dummer R, Scarisbrick J, Quaglino P, Zinzani PL, et al; ALCANZA study group. Brentuximab vedotin or physician's choice in CD30-positive cutaneous T-cell lymphoma (ALCANZA): an international, open-label, randomised, phase 3, multicentre trial. Lancet 2017; 390 (10094): 555-66. (Among 131 patients with refractory T cell lymphomas treated with brentuximab vedotin or standard therapy, objective response rates were 56% vs 13%, and neuropathy occurred in 45% vs 2%; no mention of ALT elevations or hepatotoxicity). 28600132
Fong M, Boyle S, Gutta N. Brentuximab vedotin in combination with sequential procarbazine, cyclophosphamide and prednisolone for the management of Hodgkin's lymphoma-associated vanishing bile duct syndrome (VBDS) with severe obstructive liver failure. BMJ Case Rep. 2019;12:e227676. (39 year old woman with Hodgkin disease and vanishing bile duct syndrome [bilirubin rising to 26.3 mg/dL] was treated with cycles of cyclophosphamide and prednisone, with addition of procarbazine [cycle 3] and brentuximab vedotin [cycle 4] had an eventual excellent response [by cycle 7] and return of liver tests to normal, allowing for subsequent treatment with first line therapy [ABVD]). 30796069
Neeman J, Friedman A, McKendrick J. Acute liver injury leading to death in the setting of brentuximab vedotin monotherapy. Leuk Lymphoma. 2019;60:2283-2286. (67 year old man with composite lymphoma for 11 years was treated with brentuximab vedotin after his third relapse resulting in a partial response but presentation with jaundice and fever after the 7^th^ cycle [bilirubin 11.2 mg/dL, ALT 206 U/L, Alk P 745 U/L], a liver biopsy showing cholestatic hepatitis and subsequent progressive course and death from hepatic failure 3-4 weeks later; mentions that the sponsor knew of 5 other possible cases of brentuximab vedotin severe liver injury). 30822188
Ishitsuka K, Yokoyama Y, Baba N, Matsuoka R, Sakamoto N, Sakamoto T, Kusakabe M, et al. Administration of brentuximab vedotin to a Hodgkin lymphoma patient with liver dysfunction due to vanishing bile duct syndrome resulting in a partial response without any severe adverse events. J Clin Exp Hematop. 2022;62:154-157. (35 year old man with Hodgkin lymphoma and vanishing bile duct syndrome [bilirubin rising to 19.9 mg/dL, Alk P to 2861 U/L] failed to respond to convention anti-lymphoma therapies, but had a partial response and improvement in liver tests with full dose cycles of brentuximab vedotin). 35831099
Wang Y, Wang Z, Wei C, Zhao D, Zhang Y, Wang W, Zhang W, et al. Single-agent brentuximab vedotin as frontline therapy for Hodgkin lymphoma patients with severe hepatic impairment: a report of two cases. Ann Hematol. 2023;102:2973-2975. (Two cases, 51 year old woman and 31 year old man who presented with Hodgkin disease and severe liver test abnormalities [bilirubin 27.4 mg/dL in one, ALT 1122 U/L in the other], both had improvements in liver tests with first line therapy with brentuximab vedotin and allowed for later use of radiation or ABVD therapy achieving complete remissions). 37522969
Sun C, Yang X, Tang L, Chen J. A pharmacovigilance study on drug-induced liver injury associated with antibody-drug conjugates (ADCs) based on the food and drug administration adverse event reporting system. Expert Opin Drug Saf. 2023:1-12. (Analysis of the FDA reporting system [FAERS] for cases of drug induced liver injury submitted between 2004 and 2022, found 17,784 reports, 504 [3%] attributed to antibody-drug conjugates, 202 from the US, the implicated agents being gemtuzumab ozogamicin [n=98], brentuximab vedotin [n=37], trastuzumab emtansine [n=25], enfortumab vedotin [n=16], inotuzumab ozogamicin [n=15], transtuzumab deruxtecan [n=8], and polatuzumab vedotin [3]). 37898875

## OTHER REFERENCE LINKS

Recent References on Brentuximab vedotin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Brentuximab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Brentuximab vedotin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Brentuximab)